# Imatinib

## OVERVIEW

### Introduction

Imatinib is specific tyrosine kinase receptor inhibitor that is used in the therapy of Philadelphia chromosome-positive chronic myelogenous leukemia (CML) and gastrointestinal stromal tumors (GIST), both of which are marked by an abnormal, constitutively expressed tyrosine kinase that causes unregulated cell growth. Imatinib therapy is associated with transient elevations in serum aminotransferase levels and rare instances of clinically apparent acute liver injury which can be severe and sometimes fatal. It can also cause reactivation of hepatitis B.

### Background

Imatinib (im a' ti nib) is a specific inhibitor of the unique bcr-abl tyrosine kinase receptor, which is the product of a fusion gene resulting from the translocation between chromosomes 9 and 22 that characterizes the Philadelphia chromosome (Ph) that is found in patients with chronic myelogenous leukemia (CML). The abnormal tyrosine kinase receptor is constitutively expressed and causes abnormal cell growth and proliferation. Introduction of imatinib into clinical medicine was an important advance in the therapy of cancer, the first antineoplastic agent specifically directed at a molecular abnormality that occurs in cancer cells. Inhibition of the receptor can lead to dramatic reversal of progression of Ph+ leukemia and is highly effective, although limited by the development of tumor resistance caused by mutations in the kinase. A similar abnormal tyrosine kinase (cKit) receptor which is also inhibited by imatinib is found in gastrointestinal stromal tumors (GIST). Imatinib received accelerated approval for use in the United States in May 2001 and subsequent full approval in December 2005. Current indications are for Philadelphia chromosome positive (Ph+) CML and Ph+ acute lymphoblastic leukemia, for unresectable or metastatic GIST with positive Kit (CD117) and for other malignant syndromes with other kinase mutations sensitive to imatinib including myelodysplastic disorders and systemic mastocytosis. Imatinib is available in tablets of 100 and 400 mg generically and under the brand name Gleevec. The typical dose is 400 to 600 mg once daily. Side effects include nausea, edema, muscle cramps, arthralgias, fatigue, fever, headache, abdominal discomfort, diarrhea, anemia, cough, rash and pruritus. Rare, but potentially severe adverse events include severe myelosuppression, congestive heart failure, cardiogenic shock, hemorrhage, severe rash, embryo-fetal toxicity, tumor lysis syndrome, renal toxicity and growth retardation.

### Hepatotoxicity

Imatinib therapy is associated with three forms of acute liver injury: transient and usually asymptomatic elevations in serum enzymes during treatment, clinically apparent acute hepatitis, and reactivation of an underlying chronic hepatitis B.

Elevations in serum aminotransferase levels are common during imatinib therapy, and ALT levels above 5 times the upper limit of the normal range occur in 2% to 4% of patients treated for 6 months or more. In addition, mild elevations in serum bilirubin can occur. These abnormalities are usually mild, asymptomatic, and resolve despite continuing therapy. Nevertheless, dose adjustment or temporary discontinuation and restarting at a lower dose may be needed, and temporary discontinuation is prudent if levels are markedly elevated (ALT or AST persistently above 5 times ULN or bilirubin above 3 times ULN).

In addition, imatinib has been linked to rare instances of clinically apparent acute liver injury with jaundice. The time to onset has varied from 6 days to as long as several years after starting treatment, the usual latency being 2 to 6 months (Cases 1 and 2). The pattern of serum enzyme elevations is typically hepatocellular, although atypical cholestatic and mixed forms of hepatitis have also been reported. The injury can be severe, and instances of acute liver failure and death have been reported as well as severe hepatitis resulting in a posthepatitic cirrhosis. Immune allergic features (rash, fever and eosinophilia) are not common, but some patients develop low levels of autoantibodies and instances of chronic hepatitis on long term imatinib have been reported. The severe and fatal cases can arise despite the prompt discontinuation of imatinib when monitoring reveals elevations in serum aminotransferase levels and before jaundice is present. More importantly, many instances of an apparent clinical response to prednisone therapy have been described suggesting that corticosteroid therapy should be started promptly if liver tests worsened even when imatinib is stopped. Recurrence of injury is common with reexposure, but concurrent prednisone therapy may blunt or prevent the recurrence of liver injury and, in some instances, has allowed for continued, long term therapy despite a previous bout of clinically apparent liver injury on imatinib.

Finally, there have been several instances of reactivation of chronic hepatitis B during imatinib therapy in patients with concurrent inactive hepatitis B or the HBsAg carrier state (Case 3). The clinical presentation is generally with an acute hepatitis like syndrome with marked elevations in serum ALT and minimal changes in alkaline phosphatase levels. Typically, hepatitis B virus (HBV) DNA is present in serum in increasing levels early in the course of reactivation which rapidly falls to pretreatment levels with recovery. Patients may also test positive for IgM antibody to hepatitis B core antigen (IgM anti-HBc). Reactivation of hepatitis B due to imatinib can be severe and fatal instances have been reported.

Likelihood score: A (well documented cause of clinically apparent liver injury as well as reactivation of hepatitis B).

### Mechanism of Injury

The immune features and response to prednisone therapy suggest that the hepatic injury is immunologically mediated. However, there may be multiple causes of liver injury with imatinib therapy. Reactivation of hepatitis B is probably caused by immune suppression leading to increased viral replication, followed by immune recovery and acute liver injury.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. In some situations, therapy can be restarted particularly with concurrent prednisone (10 mg to 20 mg daily). In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors and, in many situations, switching to another tyrosine kinase inhibitor may be appropriate. Cases of acute liver failure have occurred in patients receiving imatinib. In using this medication, other potentially hepatotoxic agents should be avoided. Patients with reactivation of hepatitis B usually recover spontaneously, but therapy with an oral antiviral agent active against HBV is often used. Importantly, patients who are to receive long term therapy with imatinib should be screened for hepatitis B and, if positive, given antiviral prophylaxis against reactivation (with an oral antiviral agent with potent activity against HBV such as entecavir or tenofovir) or monitored prospectively and started on antiviral therapy if HBV DNA levels rise.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Drugs in the Subclass, Chronic Myeloid Leukemia Agents: Bosutinib, Dasatinib, Nilotinib, Omacetaxine, Ponatinib

## CASE REPORTS

### Case 1. Severe acute hepatitis during imatinib therapy.(1)

A 53 year old woman with unresectable gastrointestinal stromal tumors developed fatigue and liver test abnormalities 10 weeks after starting imatinib therapy (400 mg daily). She had no history of liver disease and was known to have had normal liver tests before starting imatinib (Table). She drank little alcohol, had no risk factors for viral hepatitis, and was taking no other medications. Laboratory tests showed marked elevations in serum aminotransferase levels (ALT 944 U/L, AST 678 U/L), with minimal increases in alkaline phosphatase (195 U/L) and normal bilirubin (1.2 mg/dL). Imatinib was stopped, but over the next week she continued to worsen. She was admitted for management of the liver injury. On admission, she was jaundiced and had a flapping tremor. Abdominal ultrasound showed mild ascites, but normal liver texture and no evidence of biliary obstruction. Tests for hepatitis A, B and C were negative as were autoimmune markers. Because of the worsening clinical syndrome, prednisolone was started (40 mg daily), whereupon she began to improve. A liver biopsy showed centrilobular necrosis, inflammation and interface hepatitis. Rapid tapering of prednisolone was followed by a transient increase in ALT levels, but eventually all liver tests returned to normal, and corticosteroids were stopped. She was later treated with sunitinib (another tyrosine kinase inhibitor) without recurrence of liver injury.

#### Key Points

Medication: | Imatinib (400 mg daily)
Pattern: | Hepatocellular (R=17.4)
Severity: | 4+ (jaundice, hospitalization, ascites and hepatic encephalopathy)
Latency: | 10 weeks
Recovery: | 12 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | 11 | 69 | 0.6 | Imatinib started
4 weeks | Pre | 15 | 77 | 0.8
10 weeks | 0 | 994 | 195 | 2.3 | Imatinib stopped
11 weeks | 8 days | 1234 | 203 | 7.8 | Admitted
| 9 days | 1276 | 205 | 9.8 | Prednisolone started
| 10 days | 1173 | 208 | 9.3
12 weeks | 2 weeks | 384 | 185 | 3.5
13 weeks | 3 weeks | 199 | | 3.1
15 weeks | 5 weeks | 246 | 140 | 1.0
4 months | 6 weeks | 46 | 100 | 0.9 | Liver biopsy
5 months | 9 weeks | 14 | 115 | 1.1 | Prednisolone stopped
Normal Values | | <40 | <142 | <1.2

#### Comment

An acute viral hepatitis-like syndrome arose after 10 weeks of imatinib therapy. While autoantibodies were not detected, the hepatotoxicity of imatinib has many features suggestive of immunologically mediated injury and appears to respond to immunosuppressive therapy. The marked worsening of the clinical condition of this patient led to initiation of high dose prednisolone therapy, which was rapidly followed by clinical improvement. An attempt to lower the dose of prednisolone (from 40 to 10 mg daily) after only two weeks of treatment was followed by worsening of liver tests, and the dose was increased until serum aminotransferase levels had fallen into the normal range. Eventually, corticosteroids were stopped and there was no recurrence of liver injury.

### Case 2. Acute liver failure due to imatinib.(2)

A 51 year old woman with chronic myelogenous leukemia (CML) developed fatigue and serum aminotransferase elevations 5 months after starting imatinib therapy (400 mg daily). Imatinib was discontinued, but her symptoms and liver tests worsened, and she was admitted for evaluation two weeks later. She had no history of liver disease and serum enzymes had been normal before treatment (Table). She did not drink alcohol, had no risk factors for liver hepatitis and was not taking any other medications. Physical examination showed jaundice, but no signs of chronic liver disease or evidence of encephalopathy. At this point, serum bilirubin was 8.4 mg/dL, ALT 3185 U/L, AST 2224 U/L, and alkaline phosphatase 648 U/L. The prothrombin time index (protime) was 30%. Tests for hepatitis A, B and C were negative as were routine autoantibodies. Abdominal ultrasound showed the liver to be reduced in size, but without evidence of extrahepatic obstruction. There was mild ascites. Over the next few days, her clinical condition worsened, the prothrombin index fell to 6% and she developed hepatic encephalopathy. She was referred for liver transplantation, but required vasopressors and mechanical ventilation and died of multiorgan failure before a donor liver became available.

#### Key Points

Medication: | Imatinib (400 mg daily)
Pattern: | Hepatocellular (R=30.5)
Severity: | 5+ (acute liver failure and death)
Latency: | 5 months
Recovery: | None
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | 55 | 197 | 0.5
8 weeks | | 13 | 330 | 0.3
18 weeks | | 49 | 204 | 0.5
20 weeks | 0 | 1493 | 288 | 0.7 | Imatinib stopped
22 weeks | 14 days | 3185 | 648 | 8.4 | Admission
| 16 days | 3028 | 668 | 12.2 | Protime 30%
23 weeks | 21 days | 1941 | 831 | 25.4 | Protime 13%
| 22 days | 1767 | 800 | 21.4 | Encephalopathy
24 weeks | 4 weeks | 900 | 686 | 24.7
| Died of multiorgan failure
Normal Values | | <35 | <240 | <1.2

#### Comment

Despite prompt discontinuation of imatinib, this patient progressed to acute liver failure and died 4 weeks after onset of initial symptoms of liver injury and stopping therapy. In the first 10 years of imatinib availability, there have been over a dozen case reports of clinically apparent acute liver injury due to imatinib, and at least 6 instances of acute liver failure resulting in death or need for emergency liver transplantation.

### Case 3. Severe reactivation of hepatitis B due to imatinib.(3)

A 48 year old man with chronic myelogenous leukemia (CML) and the HBsAg carrier state developed nausea, weakness and jaundice accompanied by evidence of reactivation of hepatitis B, 9 months after starting imatinib. Before treatment, he was known to have normal serum aminotransferase levels and tested positive for HBsAg with low levels of HBV DNA (<2,000 copies/mL). In addition, he was HBeAg negative and anti-HBe positive. After the diagnosis of Philadelphia chromosome positive CML in the chronic phase, he was initially treated with hydroxyurea for 3 weeks and then switched to imatinib [400 mg daily]. Serum aminotransferase levels were monitored regularly (Table). Nine months after starting imatinib, he developed symptoms of liver disease and was found to be jaundiced. Laboratory tests showed total serum bilirubin of 8.3 mg/dL, ALT 254 U/L and HBV DNA of 100 million copies/mL. Tests for hepatitis A and C were negative as were tests for Epstein Barr virus and cytomegalovirus infection. Ultrasonography showed no evidence of biliary obstruction, but did reveal an echogenic liver and mild splenomegaly. Despite stopping imatinib and starting lamivudine, his condition deteriorated with steady rise of serum bilirubin to a peak of 53 mg/dL, worsening prothrombin time and appearance of hepatic encephalopathy. A living donor liver transplantation was done approximately two months after presentation with jaundice. The explant showed a macronodular cirrhosis with superimposed submassive necrosis, inflammation and cholestasis. He recovered rapidly and was discharged within 6 weeks of surgery. In follow up, his serum bilirubin and enzymes remained normal, and HBV DNA fell to undetectable levels. He remained on lamivudine and 7 months after transplantation he was restarted on imatinib without further complications.

#### Key Points

Medication: | Imatinib (200 mg daily)
Pattern: | Probably hepatocellular
Severity: | 5+ (liver transplantation)
Latency: | 9 months
Recovery: | None
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | HBV DNA (copies/mL) | Bilirubin (mg/dL) | Other
0 | Pre | 34 | <2000 | 0.9 | HBsAg positive
0 | | 30 | | 0.9
3 month* | | 60 | | 0.7
6 months* | | 70 | | 1.0 | Imatinib stopped
9 months | 0 | 254 | 100 million | 8.4 | Admission
| 2 weeks | 280 | | 22 | Protime 54%
10 months | 4 weeks | 310 | | 28
| 6 weeks | 160 | | 43
11 months | 8 weeks | 90 | | 53 | Protime 27%
| | Living donor liver transplant performed
12 months | 13 weeks | 50 | | 1.3 | Discharged
15 months | 6 months | 29 | <2000 | 0.5
18 months | 10 months | 30 | | 0.5 | Imatinib Restarted
22 months | 14 months | 30 | | 0.8
Normal Values | | <40 | None | <1.2

* Several values and times are estimated from Figure 1.

#### Comment

Reactivation of chronic hepatitis B typically occurs in patients given corticosteroids or cancer chemotherapy who are HBsAg positive but have minimal liver disease and low levels of HBV DNA and no detectable HBeAg in serum. The immune suppression causes an increase in HBV replication with a rise in HBV DNA to high levels; HBeAg may also reappear. Subsequent partial immune restoration is accompanied by an immunologic response to HBV antigens and a flare of the hepatitis B. Reactivation is well known to occur with cancer chemotherapy, particularly with high doses of corticosteroids or rituximab. Reactivation can also be caused by tumor necrosis factor antagonists such as infliximab. The appearance of hepatitis B reactivation during therapy with imatinib, however, came as a surprise, as this therapy was not thought to cause significant immune suppression and was not suspected of altering HBV replication. Nevertheless, several very convincing instances of reactivation of hepatitis B have now been linked to imatinib therapy arising 3 months to more than a year after starting therapy. Reactivation of hepatitis B can be severe and has a mortality rate of at least 10%. While not shown to be effective in patients receiving imatinib, prophylaxis with antiviral agents has been shown to prevent or ameliorate hepatitis B reactivation after cancer chemotherapy and therefore can be recommended for patients with HBsAg in serum who are scheduled to receive imatinib therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Imatinib – Gleevec®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Imatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Imatinib | 152459-95-5 | C29-H31-N7-O

## CITED REFERENCES

1 Tonyali O, Coskun U, Yildiz R, Karakan T, Demirci U, Akyurek N, Benekli M, et al. Imatinib mesylate-induced acute liver failure in a patient with gastrointestinal stromal tumors. Med Oncol 2010; 27: 768-73.19662540
2 Ridruejo E, Cacchione R, Villamil AG, Marciano S, Gadano AC, Mandó OG. Imatinib-induced fatal acute liver failure. World J Gastroenterol 2007; 13: 6608-111.18161937
3 Kang BW, Lee SJ, Moon JH, Kim SN, Chae YS, Kim JG, Hwang YJ, Sohn SK. Chronic myeloid leukemia patient manifesting fatal hepatitis B virus reactivation during treatment with imatinib rescued by liver transplantation: case report and literature review. Int J Hematol 2009; 90: 383-7.19641858

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2025

Abbreviations used: CML, chronic myelogenous leukemia; GIST, gastrointestinal stromal tumor

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of imatinib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. pp. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses the interactions of imatinib with CYP 3A4; ALT elevations of >5 times ULN occur in 1-3% of patients on imatinib alone and in 53% of those receiving imatinib in combination with other agents; 5 reports of liver injury have been published including one case of acute liver failure).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Druker BJ, Talpaz M, Resta DJ, Peng B, Buchdunger E, Ford JM, Lydon NB, et al. Efficacy and safety of a specific inhibitor of the BCR-ABL tyrosine kinase in chronic myeloid leukemia. N Engl J Med 2001; 344: 1031-7. (Phase 1 trial of imatinib in 83 patients with chronic myelogenous leukemia [CML]; side effects included nausea, myalgias, edema and rash; no mention of hepatotoxicity or ALT elevations). 11287972
Demetri GD, von Mehren M, Blanke CD, Van den Abbeele AD, Eisenberg B, Roberts PJ, Heinrich MC, et al. Efficacy and safety of imatinib mesylate in advanced gastrointestinal stromal tumors. N Engl J Med 2002; 347: 472-80. (Randomized trial of 400 vs 600 mg of imatinib in 147 patients with gastrointestinal stromal tumors [GIST]; 54% had abnormal liver tests, but no details given). 12181401
Elliott MA, Mesa RA, Tefferi A. Adverse events after imatinib mesylate therapy. N Engl J Med 2002; 346: 712-3. (Among 26 patients with malignancies treated with imatinib, 3 developed splenic rupture; all had splenomegaly and presented within 12-40 days with left upper quadrant pain requiring splenectomy). 11870257
Kantarjian H, Sawyers C, Hochhaus A, Guilhot F, Schiffer C, Gambacorti-Passerini C, Niederwieser D, et al.; International STI571 CML Study Group. Hematologic and cytogenetic responses to imatinib mesylate in chronic myelogenous leukemia. N Engl J Med 2002; 346: 645-52. (Open label study of imatinib in 532 patients with CML who had failed previous therapy; complete hematologic response occurred in 95% of patients; discontinuation for side effects was required in 2.1% and 4 patients had serious "hepatic toxic effects", but no details given). 11870241
Schwetz BA. From the Food and Drug Administration. JAMA 2002; 287: 1103. (Announcement of approval of imatinib for unresectable or metastatic malignant gastrointestinal stromal tumors [GIST]). 11879090
Ohyashiki K, Kuriyama Y, Nakajima A, Tauchi T, Ito Y, Miyazawa H, Kimura Y, et al. Imatinib mesylate-induced hepato-toxicity in chronic myeloid leukemia demonstrated focal necrosis resembling acute viral hepatitis. Leukemia 2002; 16: 2160-1. (56 year old woman with CML developed rash and fatigue 11 days after starting imatinib [bilirubin 3.8 mg/dL, ALT 342 U/L, Alk P 435 U/L, without fever or eosinophilia], resolving in 3 weeks). 12357373
Sawyers CL, Hochhaus A, Feldman E, Goldman JM, Miller CB, Ottmann OG, Schiffer CA, et al. Imatinib induces hematologic and cytogenetic responses in patients with chronic myelogenous leukemia in myeloid blast crisis: results of a phase II study. Blood 2002; 99: 3530-9. (Phase 2 trial of 400 or 600 mg of imatinib in 260 patients with CML in blast crisis; discontinuation for side effects occurred in 5% and was due to abnormal liver tests in one; ALT levels above 5 times ULN occurred in 2% and bilirubin >3 times ULN in 4%). 11986204
Talpaz M, Silver RT, Druker BJ, Goldman JM, Gambacorti-Passerini C, Guilhot F, Schiffer CA, et al. Imatinib induces durable hematologic and cytogenetic responses in patients with accelerated phase chronic myeloid leukemia: results of a phase 2 study. Blood 2002; 99: 1928-37. (Phase 2 trial comparing 400 vs 600 mg of imatinib in 235 patients with CML; ALT elevations >5 times ULN occurred in 3% and bilirubin in 2%; one death from acute liver failure within 12 days of starting imatinib). 11877262
O'Brien SG, Guilhot F, Larson RA, Gathmann I, Baccarani M, Cervantes F, Cornelissen JJ, et al.; IRIS Investigators. Imatinib compared with interferon and low-dose cytarabine for newly diagnosed chronic-phase chronic myeloid leukemia. N Engl J Med 2003; 348: 994-1004. (Controlled trial of imatinib vs interferon alfa and cytarabine in 1106 patients with CML; ALT elevations occurred in 43% of patients on imatinib and were above 5 times ULN in 5.1%, but no deaths from liver disease). 12637609
Lin NU, Sarantopoulos S, Stone JR, Galinsky I, Stone RM, Deangelo DJ, Soiffer RJ. Fatal hepatic necrosis following imatinib mesylate therapy. Blood 2003; 102: 3455-6. (61 year old woman with polycythemia vera and myelofibrosis developed raised enzymes 7 weeks after starting imatinib [ALT 145 rising to 1041 U/L], with subsequent acute liver failure, lactic acidosis, shock and death; autopsy showing coagulative necrosis). 14568907
James C, Trouette H, Marit G, Cony-Makhoul P, Mahon FX. Histological features of acute hepatitis after imatinib mesylate treatment. Leukemia 2003; 17: 978-9. (2 cases of marked ALT elevations [2430 and 159 U/L] in 58 and 35 year old women treated with imatinib for CML for 5 and 12 months, one with jaundice [bilirubin 21.9 mg/dL], resolving with stopping and recurring in both with restarting). 12750713
Rocca P, El Jastimi S, Troncy J, Scoazec JY, Boucher A, Vial T, Trepo C, et al. [Imatinib mesylate-induced acute cytolytic hepatitis]. Gastroenterol Clin Biol 2004; 28: 918-9. French. PMID: 15523233 (64 year old woman with CML developed ALT elevations 2 months after starting imatinib, with recurrence on restarting [bilirubin 5.7 mg/dL, ALT 28 times ULN, Alk P 3 times ULN], resolving in 3 months and recurring 2 weeks after restarting again).
Kikuchi S, Muroi K, Takahashi S, Kawano-Yamamoto C, Takatoku M, Miyazato A, Nagai T, et al. Severe hepatitis and complete molecular response caused by Imatinib mesylate: possible association of its serum concentration and clinical outcomes. Leuk Lymphoma 2004; 45: 2349-51. (40 year old woman with CML developed jaundice 5 months after starting imatinib [bilirubin 2.7 rising to 10 mg/dL, ALT 559 U/L, prothrombin index 46%], resolving within 2 months of stopping). 15512829
Ikuta K, Torimoto Y, Jimbo J, Inamura J, Shindo M, Sato K, Tokusashi Y, et al. Severe hepatic injury caused by imatinib mesylate administered for the treatment of chronic myeloid leukemia and the efficacy of prednisolone for its management. Int J Hematol 2005; 82: 343-6. (51 year old woman with CML developed fatigue 3 months after starting imatinib [bilirubin 14.0 mg/dL, ALT 167 U/L, Alk P 403 U/L, prothrombin index 61%], recurring upon restarting at low dose, but not recurring when given with prednisone [20 mg/day] which later was tapered and stopped). 16298828
Ayoub WS, Geller SA, Tran T, Martin P, Vierling JM, Poordad FF. Imatinib (Gleevec)-induced hepatotoxicity. J Clin Gastroenterol 2005; 39: 75-7. (22 year old woman with CML developed jaundice 1 month after starting imatinib and after trip to Mexico [bilirubin 10.4 rising to 25.6 mg/dL, ALT 1337 U/L, Alk P 398 U/L], resolving 3 months after stopping). 15599217
Cohen MH, Johnson JR, Pazdur R. U.S. Food and Drug Administration Drug Approval Summary: conversion of imatinib mesylate (STI571; Gleevec) tablets from accelerated approval to full approval. Clin Cancer Res 2005; 11: 12-9. (Summary of studies upon which FDA gave approval of imatinib for CML in chronic phase after failure of other therapy or accelerated phase or blast crisis; elevations in ALT >5 times ULN occurred in 2-4% of cases, and one patient [also taking acetaminophen] died of acute liver failure). 15671523
Ferrero D, Pogliani EM, Rege-Cambrin G, Fava C, Mattioli G, Dellacasa C, Campa E, et al. Corticosteroids can reverse severe imatinib-induced hepatotoxicity. Haematologica 2006; 91 (6 Suppl): ECR27. (5 cases of ALT and AST elevations 3-8 months after starting imatinib for CML [ALT 183-1080 U/L, bilirubin and Alk P normal]; recurrence on restarting, but not if combined with prednisone, which allowed long term therapy). 16785130
Zonder JA, Schiffer CA. Update on practical aspects of the treatment of chronic myeloid leukemia with imatinib mesylate. Curr Hematol Malig Rep 2006; 1: 141-51. (Review of use of imatinib in CML; hepatic toxicity occurs in 1-3% but is rarely so severe to require drug discontinuation). 20425345
Pariente A, Etcharry F, Cales V, Laborde Y, Ferrari S, Biour M. Imatinib mesylate-induced acute hepatitis in a patient treated for gastrointestinal stromal tumour. Eur J Gastroenterol Hepatol 2006; 18: 785-7. (Woman with GIST developed fatigue 6 weeks after starting imatinib [bilirubin 0.9 rising to 3.3 mg/dL, peak ALT 66 times ULN, Alk P 1.9 times ULN], resolving within 6 weeks of stopping and recurring rapidly on restarting [ALT 10 times ULN] even in lower doses [ALT 2.5 times ULN], later treated with sunitinib without recurrence of liver injury). 16772838
Dhalluin-Venier V, Besson C, Dimet S, Thirot-Bibault A, Tchernia G, Buffet C. Imatinib mesylate-induced acute hepatitis with autoimmune features. Eur J Gastroenterol Hepatol 2006; 18: 1235-7. (18 year old woman with CML developed asymptomatic serum enzyme elevations 2 weeks after starting imatinib [bilirubin 0.4 mg/dL, ALT 227 U/L, Alk P 74 U/L ], ALT rising [755 U/L with continuation and staying high [973 U/L] until prednisone was given [17 U/L]; positive rechallenge even with prednisone [137 U/L] and later switched to interferon: anti-liver cytosol antibody was 1:640, but ANA negative). 17033447
Cross TJ, Bagot C, Portmann B, Wendon J, Gillett D. Imatinib mesylate as a cause of acute liver failure. Am J Hematol 2006; 81: 189-92. (46 year old woman with CML had remission on long-term imatinib [18 months], but developed nausea a few weeks after stopping and restarting imatinib, progressing to acute liver failure [bilirubin 26 mg/dL, AST 201 U/L, Alk P 84 U/L, INR 2.8] and undergoing liver transplantation but dying postoperatively, explants showing confluent necrosis and collapse). 16493605
Ikeda K, Shiga Y, Takahashi A, Kai T, Kimura H, Takeyama K, Noji H, et al. Fatal hepatitis B virus reactivation in a chronic myeloid leukemia patient during imatinib mesylate treatment. Leuk Lymphoma 2006; 47: 155-7. (54 year old man with CML and both chronic hepatitis B and C developed fatigue and jaundice 5 months after starting imatinib [bilirubin 5.6 rising to 25 mg/dL, ALT 1574 U/L, prothrombin index 14%, high levels of HBV DNA polymerase and no detectable HCV RNA], with progressive hepatic failure and death 5 weeks after stopping). 16321842
Mindikoglu AL, Regev A, Bejarano PA, Martinez EJ, Jeffers LJ, Schiff ER. Imatinib mesylate (gleevec) hepatotoxicity. Dig Dis Sci 2007; 52: 598-601. (72 year old man with CML developed enzyme elevations [ALT 90 rising to 114 U/L] which worsened for 4 weeks after stopping [ALT 1894 U/L, Alk P 125 U/L, bilirubin 1.1 mg/dL] and peaked at 7-9 weeks [ALT 2200 U/L, bilirubin 9.0 mg/dL], thereafter decreasing to normal). 17219077
Ridruejo E, Cacchione R, Villamil AG, Marciano S, Gadano AC, Mandó. Imatinib-induced fatal acute liver failure. World J Gastroenterol 2007; 13: 6608-111. (51 year old woman with CML developed weakness 5 months after starting imatinib [bilirubin 0.7 rising to 36 mg/dL, ALT 1493 U/L, Alk P 288 U/L], with progression to acute liver failure and death awaiting liver transplant 1 month after onset: Case 2). 18161937
Kong JH, Yoo SH, Lee KE, Nam SH, Kwon JM, Lee SM, Chang HJ, et al. Early imatinib-mesylate-induced hepatotoxicity in chronic myelogenous leukaemia. Acta Haematol 2007; 118: 205-8. (64 year old man with CML developed rash, edema and dark urine 10 days after starting imatinib [bilirubin 18.9 mg/dL, ALT 610 U/L, Alk P 937 U/L, 12% eosinophils], resolving within 6 weeks; later restarted and had rashes, but no further hepatotoxicity). 18030002
Fuster F, Medina L, Vallansot R, Granell M, Bruguera M. [Imatinib-induced toxic hepatitis: description of two cases and review of the literature]. Gastroenterol Hepatol 2007; 30: 525-30. (3 patients, ages 46-58 years old, treated with imatinib for CML developed ALT elevations at 4-8 months and resolving in 2 months; a third said to develop fatal acute liver failure, but few details given). 17980129
Al Sobhi E, Zahrani Z, Zevallos E, Zuraiki A. Imatinib-induced immune hepatitis: case report and literature review. Hematology 2007; 12: 49-53. (17 year old woman with CML developed jaundice 1.5 years after starting imatinib [bilirubin 4.1 mg/dL, ALT 570 U/L, Alk P 336 U/L, ANA positive], improving on stopping imatinib and worsening again on restarting 3 weeks later, and then persisting for several months despite stopping, responding ultimately to prednisolone therapy). 17364993
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one case was attributed to imatinib). 18955056
Lin AY, Fisher GA, So S, Tang C, Levitt L. Phase II study of imatinib in unresectable Hepatocellular carcinoma. Am J Clin Oncol 2008; 31: 84-8. (15 patients with unresectable hepatocellular carcinoma [7 with chronic hepatitis B] were treated with imatinib for up to 3 months; no patients had a tumor response, 9 had ALT elevations [but all <5 times ULN], few details given). 18376233
Lakhani S, Davidson L, Priebat DA, Sherker AH. Reactivation of chronic hepatitis B Infection related to imatinib mesylate therapy. Hepatol Int 2008; 2: 498-9. (50 year old man with desmoid tumor and chronic HBsAg carrier state developed fatigue and rising ALT levels 3 months after starting imatinib with subsequent jaundice [peak bilirubin 7.1 mg/dL, ALT 2120 U/L, HBV DNA 29 million IU/mL, protime normal], resolving within 6 weeks of stopping with fall in HBV DNA levels [~3000 IU/mL]). 19669326
Thia TJ, Tan HH, Chuah TH, Chow WC, Lui HF. Imatinib mesylate-related fatal acute hepatic failure in a patient with chronic myeloid leukaemia and chronic hepatitis B infection. Singapore Med J 2008; 49 (3): e86-9. (45 year old man with CML and chronic hepatitis B [HBV DNA 300,000 copies/mL] developed jaundice 5 months after starting imatinib [bilirubin 10.7 mg/dL, ALT 4193 U/L, Alk P 144 U/L, protime 25.9 sec, HBV DNA >100 million copies/mL], with rapidly evolving hepatic failure and death on hospital day 8). 18362995
Kang BW, Lee SJ, Moon JH, Kim SN, Chae YS, Kim JG, Hwang YJ, Sohn SK. Chronic myeloid leukemia patient manifesting fatal hepatitis B virus reactivation during treatment with imatinib rescued by liver transplantation: case report and literature review. Int J Hematol 2009; 90: 383-7. (48 year old man with CML and chronic hepatitis B developed nausea followed by jaundice 9 months after starting imatinib [bilirubin 8.3 rising to 50 mg/dL, ALT 254 U/L, HBV DNA 100 million copies/mL, prothrombin index 54%], with worsening hepatic function despite stopping imatinib and starting lamivudine, ultimately undergoing successful liver transplant: Case 3). 19641858
Al-Kali A, Farooq S, Tfayli A. Tumor lysis syndrome after starting treatment with Gleevec in a patient with chronic myelogenous leukemia. J Clin Pharm Ther 2009; 34: 607-10. (79 year old man with CML developed acute renal failure and tumor lysis syndrome within first week of starting imatinib, resolving with supportive care; no mention of hepatic involvement). 19744017
Aliberti S, Grignani G, Allione P, Fizzotti M, Galatola G, Pisacane A, Aglietta M. An acute hepatitis resembling autoimmune hepatitis occurring during imatinib therapy in a gastrointestinal stromal tumor patient. Am J Clin Oncol 2009; 32: 640-1. (65 year old man with gastrointestinal stromal tumor developed raised ALT 1 month after starting imatinib [ALT peak 1056 U/L with normal bilirubin and Alk P], resolving in 4-5 weeks and patient was able to restart imatinib with prednisone therapy that was tapered and stopped after 6 months). 19955903
Guilhot F, Druker B, Larson RA, Gathmann I, So C, Waltzman R, O'Brien SG. High rates of durable response are achieved with imatinib after treatment with interferon alpha plus cytarabine: results from the International Randomized Study of Interferon and STI571 (IRIS) trial. Haematologica 2009; 94: 1669-75. (Among 553 patients assigned to interferon and cytarabine therapy, 359 were crossed over to imatinib and treated for an average of 4 years, ALT or AST elevations occurred in 46% and were >5 times ULN in 4.7%). 19648168
Perini GF, Santos FP, Funke V, Ruiz J, Neto BH, Hamerschlak N. Nilotinib post-liver transplantation for acute hepatic failure related to imatinib. Leuk Res 2009; 33: e234-5. (47 year old woman with CML developed jaundice and confusion after 18 months of imatinib therapy [bilirubin 20 mg/dL, ALT 828 U/L, prothrombin time 24 sec], leading to emergency liver transplantation; later treated with nilotinib without recurrence of liver injury). 19632720
Tonyali O, Coskun U, Yildiz R, Karakan T, Demirci U, Akyurek N, Benekli M, et al. Imatinib mesylate-induced acute liver failure in a patient with gastrointestinal stromal tumors. Med Oncol 2010; 27: 768-73. (53 year old woman with gastrointestinal stromal tumor developed jaundice 10 weeks after starting imatinib [bilirubin 2.3 rising to 9.8 mg/dL, ALT 994 U/L, Alk P 195 U/L], treated with prednisolone with apparent response; after withdrawal of corticosteroids, liver tests remained normal; later treated with sunitinib: Case 1). 19662540
Bilgi N, Bell K, Ananthakrishnan AN, Atallah E. Imatinib and Panax ginseng: a potential interaction resulting in liver toxicity. Ann Pharmacother 2010; 44: 926-8. (26 year old man with CML developed abdominal pain and liver test abnormalities 7 years after starting imatinib [bilirubin 1.4 mg/dL, ALT 1069 U/L, Alk P 124 U/L], having recently started ginseng, responding to prednisone therapy and stopping ginseng, ultimately able to restart imatinib). 20332334
Saglio G, Kim DW, Issaragrisil S, le Coutre P, Etienne G, Lobo C, Pasquini R, et al; ENESTnd Investigators. Nilotinib versus imatinib for newly diagnosed chronic myeloid leukemia. N Engl J Med 2010; 362: 2251-9. (Controlled trial of 2 doses of nilotinib vs imatinib in 846 patients with CML found higher response rate with nilotinib [43% and 44% vs 22%]; although most side effects were less, ALT elevations were more frequent with nilotinib than imatinib [66% and 73% vs 20% for any elevation, 4% and 9% vs 2% for elevations >5 times ULN], hepatobiliary adverse events occurred in 4 nilotinib [0.7%] and 1 imatinib [0.4%] recipient; details not given). 20525993
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to imatinib or other tyrosine kinase inhibitors). 20949552
Kim SG, Chun JM, Jin R, Kim JY, Won DI, Hwang YJ. Living donor liver transplantation for acute hepatic failure caused by reactivation of hepatitis B virus infection after chemotherapy for hematologic malignancy: case reports. Transplant Proc 2010; 42: 843-5. (49 year old man with CML and cirrhosis due to hepatitis B developed jaundice, ascites and evidence of HBV reactivation more than a year after starting therapy with imatinib [peak bilirubin 50.8 mg/dL, HBV DNA 4.7 million copies/mL], undergoing successful emergency living donor liver transplantation). 20430187
Spataro V. Nilotinib in a patient with postnecrotic liver cirrhosis related to imatinib. J Clin Oncol 2011; 29: e50-2. (41 year old woman with CML developed jaundice 6 months after starting imatinib [bilirubin 9.6 mg/dL, ALT 1374 U/L, Alk P 163 U/L, prothrombin index 27%, biopsy showing massive necrosis], recovering slowly with residual evidence of portal hypertension and subsequent biopsy showing cirrhosis; started on nilotinib for relapse in CML without worsening of liver tests). 20956624
Gupta S, Bhatt VR, Varma S. Recurrent imatinib-induced hepatotoxicity in a chronic myeloid leukaemia patient successfully managed with prednisone. BMJ Case Rep 2011; 2011. PMID: 22707550
(20 year old woman developed liver enzyme elevations 2 weeks after starting imatinib for CML [bilirubin 1.0 mg/dL, ALT 2364 U/L, Alk P 97 U/L], which resolved with stopping imatinib and recurred 1 week after restarting [bilirubin 2.5 mg/dL, ALT 654 U/L, Alk P 131 U/L], but not when it was restarted with prednisone which was later tapered and stopped) .
Martínez Pascual C, Valdés Mas M, de la Peña Moral JM, Miras López M. [Fulminating hepatitis for imatinib in a patient with chronic myeloid leukaemia]. Med Clin (Barc) 2011; 137: 329-30. Spanish. PMID: 21074222 (34 year old woman with CML developed jaundice 8 months after starting imatinib [bilirubin 14.5 mg/dL, ALT 1856 U/L, Alk P 254 U/L, prothrombin index 39%], progressing within weeks to hepatic failure requiring liver transplant; explant showed massive necrosis).
García Hernández FJ, González León R, Castillo Palma MJ, Sánchez Román J. [Severe imatinib-induced hepatotoxicity]. Med Clin (Barc) 2012; 138: 638. Spanish. PMID: 22137996 (Letter in response to Martinez Pascual [2011]).
García-Valdés M, Miras López M, Garrido Corro B, De La Rubia Nieto A. [Survival following liver transplant due to imatinib-induced acute liver failure: a case study]. Farm Hosp 2012; 36: 50-1. Spanish. PMID: 21514865 (34 year old woman developed jaundice 8 months after starting imatinib for CML [direct bilirubin 14.5 mg/dL, ALT 1859 U/L, Alk P 254 U/L, prothrombin index 40%], with progressive liver failure and ultimately successful liver transplant).
Wang YD, Cui GH, Li M, Gowrea B, Xia J, Hu Y. Hepatitis B virus reactivation in a chronic myeloid leukemia patient treated with imatinib mesylate. Chin Med J (Engl) 2012; 125: 2636-7. (40 year old man developed symptomatic reactivation of hepatitis B 6 months after starting imatinib for CML [bilirubin 3.0 mg/dL, ALT 1011 U/L, INR normal, HBV DNA 285,000 IU/mL], responding to entecavir and able to continue imatinib). 22882953
Yachoui R. Early onset imatinib mesylate-induced hepatotoxicity in a patient with gastrointestinal stromal tumors. Am J Ther 2014; 21 (5): e148-50. (46 year old woman with gastrointestinal stomal tumors developed liver injury 11 days after starting imatinib, with resolution after stopping). 23567788
Lai GM, Yan SL, Chang CS, Tsai CY. Hepatitis B reactivation in chronic myeloid leukemia patients receiving tyrosine kinase inhibitor. World J Gastroenterol 2013; 19: 1318-21. (3 cases; 2 men and 1 woman, ages 43-67 years, developed reactivation of hepatitis B, 5, 15 and 53 months after starting imatinib (n=2] or nilotinib therapy of CML, with rise in ALT levels [374, 592 and 1086 U/L] and HBV DNA [2, 12 and 230 million IU/mL], but little or no jaundice [bilirubin normal, 2.54, and 2.74 mg/dL], and responding to entecavir therapy which allowed continuation of tyrosine kinase inhibitor). 23483799
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013 36: 491-503. (Systematic review of the hepatotoxicity of tyrosine kinase inhibitors, most of which have been implicated in causing ALT elevations in a high proportion of patients and almost all of which have been implicated in cases of hepatitis, and some with fatal acute liver failure [crizotinib, imatinib, lapatinib, pazopanib, ponatinib, regorafenib, sunitinib]). 23620168
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 attributed to imatinib during a period in which only 41 persons in Iceland were treated with imatinib). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 10 of which were attributed to antineoplastic agents including one due to imatinib). 24552865
Mahon C, Purvis D, Laughton S, Bradbeer P, Teague L. Imatinib mesylate-induced pseudoporphyria in two children. Pediatr Dermatol 2014; 31: 603-7. (9 and 18 year old females developed blistering of the hands 2-3 years after starting oral imatinib [serum porphyrins normal] which resolved on stopping imatinib, the rash being considered part of the spectrum of cutaneous toxicity from kinase inhibitors, partially sunlight associated but not related to porphyrin metabolism). 24920470
Yazici O, Sendur MA, Aksoy S. Hepatitis C virus reactivation in cancer patients in the era of targeted therapies. World J Gastroenterol 2014; 20: 6716-24. (Review of the effects of antineoplastic agents on hepatitis C and HCV RNA levels comments that there no reported cases of worsening on hepatitis C during imatinib therapy). 24944464
Temel T, Gunduz E, Sadigova E, Uskudar Teke H, Meric Ozgenel S, Harmanci Ozakyol A. Hepatitis B virus reactivation under treatment with nilotinib. Euroasian J Hepatogastroenterol 2015; 5: 112-4. (59 year old woman with CML and HBsAg in serum [with HBeAg but no detectable HBV DNA] received imatinib for 11 months and 1 week after switching to nilotinib developed jaundice [bilirubin 4.0 mg/dL, ALT 42, Alk P not given, HBV DNA ~500,000 IU/mL], responding rapidly to tenofovir therapy and was able to restart nilotinib). 29201705
Suzuki R, Kobayashi C, Sakai A, Fukushima H, Tagawa M, Satomi K, Nanmoku T, Sumazaki R, Fukushima T. Imatinib-induced severe hepatitis in a 9-year-old girl with Philadelphia chromosome-positive acute lymphoblastic leukemia. J Pediatr Hematol Oncol 2015; 37: e368-71. (9 year old girl with Ph+ ALL developed worsening liver tests approximately 9 months after hematopoietic cell transplant and 14 weeks after restarting imatinib [bilirubin 1.1 rising to 9.4 mg/dL, ALT 973 U/L, Alk P not given], which progressed despite stopping imatinib but resolved after starting prednisolone, a later relapse of ALL was treated unsuccessfully with dasatanib). 25929609
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents [5.5%], 9 of which were attributed to kinase inhibitors, including 5 cases due to imatinib). 25754159
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of recently approved medications including the tyrosine kinase inhibitors and imatinib which has been linked to serum enzyme elevations above 5 times ULN in 10-14% of patients and to individual cases of severe hepatotoxicity, some of which have been fatal). 27842767
Bhatty O, Selim M, Kassim T, Chintalacheruvu L, Urra M, Shah S, Haggerty J, et al. A case of imatinib-induced hepatitis. Cureus 2017; 9: e1302. (71 year old woman with CML developed jaundice 6 months after starting imatinib [bilirubin 14.7 mg/dL, ALT 1816 U/L, Alk P 132 U/L, INR 2.1] with progressive liver failure despite stopping imatinib and starting prednisone, dying of multiorgan failure 1 month later). 28690936
Nacif LS, Waisberg DR, Pinheiro RS, Lima FR, Rocha-Santos V, Andraus W, D'Albuquerque LC. Imatinib-induced fulminant liver failure in chronic myeloid leukemia: role of liver transplant and second-generation tyrosine kinase inhibitors: a case report. J Med Case Rep. 2018;12:63. (36 year old woman with CML developed liver enzyme elevations [ALT 111 U/L, AST 229 U/L] 6 months after starting imatinib and, despite stopping, went on to develop abdominal pain and jaundice 45 days later [bilirubin 13.1 mg/dL, ALT 1422 U/L, INR 2.4], leading to emergency and successful liver transplantation, explant showing massive necrosis, later tolerating dasatinib without recurrence of liver injury). 29523185
Shah JM, Lin K, Etienne D, Reddy M, Liu Y. Imatinib-induced hepatitis in a patient treated for gastrointestinal stromal tumor: a rare adverse effect. Cureus. 2018;10:e2529. (58 year old woman with GIST developed jaundice 4 months after starting imatinib [bilirubin 4.9 mg/dL, ALT 1632 U/L, Alk P 162 U/L, INR 1.9], with recovery 2 months after discontinuation). 29942731
Haq MI, Nixon J, Stanley AJ. Imatinib and liver toxicity. BMJ Case Rep. 2018;11:e226740. (49 year old woman with GIST developed fatigue and nausea within a few weeks of starting imatinib [ALT 72 U/L, Alk P and bilirubin normal] with subsequent rise leading to discontinuation, but worsening despite stopping [bilirubin 2.8 mg/dL, ALT 1614 U/L, Alk P 230 U/L] leading to corticosteroid treatment and with tapering doses, liver tests fell into the normal range within 10 weeks). 30567202
Kang MK, Lee HJ, Choi JH. Imatinib-induced hepatitis treated by corticosteroids in a patient with metastatic gastrointestinal stromal tumor. Yeungnam Univ J Med. 2019;36:155-158. (55 year old man with metastatic GIST developed elevated aminotransferase levels without symptoms 10 months after starting imatinib [bilirubin 1.6 mg/dL, ALT 393 U/L, Alk P 194 U/L, INR 1.1], and when levels worsened for 3 weeks despite stopping imatinib, corticosteroids were started with subsequent resolution, and imatinib was restarted at a lower dose without recurrence of liver abnormalities). 31620629
Han JM, Yee J, Cho YS, Gwak HS. Factors influencing imatinib-induced hepatotoxicity. Cancer Res Treat. 2020;52:181-188. (Among 177 patients with malignances treated with imatinib and monitored monthly for 3 months at a Korean referral center between 2012 and 2017, 34% developed elevations in serum ALT or AST, elevations being more frequent in those with pre-existing liver disease, on a proton pump inhibitor, with lower body weight, and receiving a high dose of imatinib). 31291714
Han JM, Han HW, Yee J, Kim MK, Moon JY, Cho S, Jung D, et al. Factors affecting high-grade hepatotoxicity of tyrosine kinase inhibitors in cancer patients: a multi-center observational study. Eur J Clin Pharmacol. 2020;76:1183-1191. (Among 1279 Korean patients with malignances treated in 5 prospective studies with kinase inhibitors [imatinib, lapatinib, erlotinib, gefitinib and crizotinib] and monitored with liver tests, 71 [5.5%] developed ALT elevations above 5 times ULN, and factors that correlated with injury in multivariant analysis included presence of liver metastases, and concurrent use of CYP 3A4 inducers). 32444938
Aqsa A, Droubi S, Amarnath S, Al-Moussawi H, Abergel J. Sunitinib-induced acute liver failure. Case Rep Gastroenterol. 2021;15:17-21. (64 year old man with end-stage renal disease on hemodialysis and pancreatic neuroendocrine cancer developed abdominal pain and jaundice 1 month after starting sunitinib [bilirubin 2.8 mg/dL, ALT 2,351 U/L, AST 5,036 U/L, Alk P 584 U/L, INR 3.1] with rapid deterioration and death within 5 days of hospitalization). 33613158
Frikha I, Fakhfakh Y, Sahnoun R, Chtourou L, Medhaffar M, Elloumi M. Imatinib mesylate-induced acute hepatotoxicity. J Oncol Pharm Pract. 2023;29:2027-2030. (51 year old man with CML developed acute toxic hepatitis 5 months after starting imatinib, which resolved 12 weeks after stopping and did not recur when switched to nilotinib). 37464887
Chen T, Li J, Wei X, Yao H, Zhu L, Liu J, Liu Y, et al. Efficiency and toxicity of imatinib mesylate combined with atorvastatin calcium in the treatment of steroid-refractory chronic graft-versus-host disease: a single-center, prospective, single-arm, open-label study. Acta Haematol. 2024;147:499-510. (Among 60 patients with corticosteroid resistant graft-vs-host disease treated with imatinib and atorvastatin for 6 months, a complete clinical response was achieved in 27% with objective response in 81% of liver manifestations and while adverse events were common (pneumonia, thrombocytopenia, pleural effusion) there was no mention of hepatic adverse events). 38232716

## OTHER REFERENCE LINKS

1. Recent References on Imatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Imatinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Imatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Imatinib)